# OxyELITE Pro

## OVERVIEW

### Introduction

OxyELITE Pro is the commercial name for a variety of multi-ingredient dietary supplements (MIDS) marketed for weight loss and body building. In 2013, one of the OxyELITE Pro products called “Super Thermogenic” was withdrawn from use in the United States after it was implicated in more than 50 cases of acute hepatitis including several instances of fatal, acute liver failure.

### Background

OxyELITE Pro is the proprietary name of a series of multi-ingredient nutritional supplements that are typically marketed as weight loss, body building, “fat burning” and performance enhancement aids. Initial ingredients in the products included caffeine and dimethylamylamine (DMAA) which in animal studies led to weight loss. Small phase 1 studies demonstrated that both blood pressure and pulse were increased with OxyELITE Pro, which was attributed to the effects of DMAA. In 2013, the FDA banned the use of DMAA in nutritional supplements and the composition of OxyELITE Pro was altered, with removal of DMAA and addition of aegeline, an herbal derivative that was believed to cause weight loss. Shortly thereafter reports of severe hepatitis were reported in persons taking “OxyELITE Pro Super Thermogenic”, some of which were severe enough to warrant emergency liver transplantation and some of which were fatal. In October 2013, under pressure from the FDA, the sponsor of OxyELITE Pro withdrew it from the market and requested retrieval of products already in distribution.

Aegeline is a component present in the fruit of the bael tree, Aegle marmelos that is native to India and is found throughout Southeast Asia. The bael tree is considered sacred in much of India and its fruit is used both as food and in Ayurvedic medicine. Extracts of bael leaves and fruit have had many uses in traditional medicine including treatment of digestive complaints and diarrhea. Its active ingredients include tannins, fatty oils, furocoumarins and furoquinolin alkaloids. The aegeline added to OxyELITE Pro was suspected to be a synthetic product, the purity of which was not clear. Other components in the OxyELITE product included caffeine (100 mg/capsule) and a propriety blend of Bauhinia purpurea leaf and pod extract, Bacopa monnieri leaf extract, dimethylamylamine (DMAA), Cirsium oligophyllum extract and Pausinystalia yohimbe bark extract (Yohimbe); none of these, however, have been implicated convincingly in causing liver injury.

### Hepatotoxicity

OxyELITE Pro has been associated with at least 50 instances of clinically apparent acute liver injury. The onset of injury was usually within 2 to 20 weeks of starting regular use or of switching to the altered formulation of OxyELITE Pro products. The typical presenting symptoms were fatigue, nausea, and abdominal pain followed by dark urine and jaundice. The pattern of liver injury was hepatocellular and serum aminotransferase levels ranged to as high as several thousand U/L while alkaline phosphatase levels tended to be normal or minimally elevated (less than 3 times ULN). Liver biopsies showed an acute hepatitis-like picture and severe cases were associated with confluent, submassive or massive necrosis. Immunoallergic and features were not common, but autoantibodies were often detected. Indeed, instances of an autoimmune hepatitis-like pattern of injury occurred in a proportion of cases, some of which led to a chronic hepatitis and required long term immune suppressive therapy despite prompt withdrawal of the agent. The mortality rate overall was approximately 10% among cases with jaundice. In most non-fatal cases, symptoms resolved within 1 to 8 weeks and laboratory tests returned to normal by two to three months.

Likelihood score: A (well documented cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of acute liver injury associated with OxyELITE Pro has been attributed to aegeline, which was added to the commercial product in early 2013. Aegeline is a derivative of the fruit and other components of the bael tree and is a commonly used herbal agent in Southeast Asia, employed in Ayurvedic medicine for digestive complains. Cases of acute liver injury have not been previously reported with aegeline use. The aegeline used in OxyELITE Pro implicated in liver injury, however, was a synthetic product produced in China and may have included contaminants, synthetic precursors, metabolic derivatives, or racemic forms of the chemical that are toxic or immunogenic.

Drug Class: Herbal and Dietary Supplements, ◦Multi-Ingredient Nutritional Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

OxyELITE Pro®

DRUG CLASS

Herbal and Dietary Supplements

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=OxyELITE%20Pro)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Aegeline | 456-12-2 | C18-H19-N-O3
Dimethylamylamine (Methylhexaneamine) | 105-41-9 | C7-H17-N

## ANNOTATED BIBLIOGRAPHY

References updated: 8 September 2021

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; OxyELITE Pro, aegeline and MDAA are not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; OxyELITE Pro, aegeline and MDAA are not mentioned).
Bael. Aegle marmelos. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 61-62. (Compilation of short monographs on herbal medications and dietary supplements).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al., Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% were attributed to herbal and dietary supplements, but none to OxyELITE Pro or MDAA).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 12 [9%] attributed to herbal supplements, but none to OxyELITE Pro or MDAA).
Bloomer RJ, Harvey IC, Farney TM, Bell ZW, Canale RE. (2011). Effects of 1,3-dimethylamylamine and caffeine alone or in combination on heart rate and blood pressure in healthy men and women. Phys Sportsmed. (10 healthy subjects received a single dose of DMAA with or without caffeine and were monitored for heart rate and blood pressure; blood pressure increased by 17-20% with DMAA, but not caffeine exposure).
Farney TM, McCarthy CG, Canale RE, Allman RJ, Bloomer RJ. (2011). Hemodynamic and hematologic profile of healthy adults ingesting dietary supplements containing 1,3-dimethylamylamine and caffeine. Nutr Metab Insights. (13 healthy volunteers took Jac3d or OxyELITE Pro [2 commercial products with DMAA and caffeine marked for weight loss] once daily for 2 weeks; heart rate and blood pressure increased with both agents 1-2 hours after administration, but returned to baseline within 24 hours and there were no significant changes in bilirubin, ALT, AST or Alk P).
Forrester M. (2013). Exposures to 1,3-dimethylamylamine-containing products reported to Texas poison centers. Hum Exp Toxicol. (Between 2010 and 2011, 56 cases of poisoning due to DMAA were reported to 6 Texas poison centers, 18 of which were unintentional ingestions by toddlers, and 8 were suicidal; the usual adverse events being nausea, vomiting and tachycardia and no reports of associated liver injury).
Centers for Disease Control and Prevention (CDC). (2013). Notes from the field: acute hepatitis and liver failure following the use of a dietary supplement intended for weight loss or muscle building--May-October 2013. MMWR Morb Mortal Wkly Rep. (29 cases of acute hepatitis were identified in Hawaii during a 5 month period in 2013 associated with taking a nutritional supplement, 24 being linked to OxyELITE Pro with onset after 7-130 days [average 60 days] and peak bilirubin 2.8-39.6 mg/dL [median 12.6], ALT 347-3091 U/L [median 1793 U/L], and Alk P 68-251 U/L [median 150 U/L], 1 patient dying and 2 undergoing liver transplantation [some cases also described in Roytman 2014]).
Roytman MM, Pörzgen P, Lee CL, Huddleston L, Kuo TT, Bryant-Greenwood P, Wong LL, Tsai N. (2014). Outbreak of severe hepatitis linked to weight-loss supplement OxyELITE Pro. Am J Gastroenterol. (Report of outbreak of acute liver injury in patients taking OxyELITE Pro at a single referral center in Hawaii, presenting between May and September 2013; 8 patients, ages 22 to 54 years, 1 man and 7 women, all Pacific-Islanders [bilirubin 1.4-41.6 mg/dL, ALT 633-2280 U/L, Alk P 146-190 U/L], 2 undergoing liver transplantation and 1 death without transplant).
Foley S, Butlin E, Shields W, Lacey B. (2014). Experience with OxyELITE Pro and acute liver injury in active duty service members. Dig Dis Sci. (7 cases of severe acute liver injury in US Military personnel taking OxyELITE Pro, ages 23 to 48 years, 3 women and 4 men, on supplement for 1 week to several years [bilirubin 1.2-32 mg/dL, ALT 176-3348 U/L, Alk P 136 U/L], 2 patients requiring liver transplantation).
Klontz KC, DeBeck HJ, LeBlanc P, Mogen KM, Wolpert BJ, Sabo JL, Salter M, et al. (2015). The role of adverse event reporting in the FDA response to a multistate outbreak of liver disease associated with a dietary supplement. Public Health Rep. (Analysis of 55 spontaneous reports of liver injury with a history of OxyELITE Pro exposure to the FDA between 2012 and 2014; laboratory analysis identified no drugs, poisons, pharmaceuticals, toxic metals or known hepatotoxic substances in retrieved products).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 130 cases of HDS associated liver injury enrolled in a US prospective study between 2004 and 2013, one of 85 herbal or nutritional supplement related cases was attributed to an OxyELITE Pro product).
Rossi S, Navarro VJ. (2014). Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality; mentions OxyELITE Pro products as being implicated in case series of liver injury from Hawaii).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality; mentions OxyELITE Pro products as having been implicated in cases of acute hepatocellular liver injury and were subject to recall).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that multi-ingredient supplements have been implicated in many cases of liver injury including proprietary agents marketed under the names Herbalife, Hydroxycut and OxyELITE Pro).
Stickel F, Shouval D. (2015). Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. (Extensive review of liver injury due to HDS mentions that OxyELITE Pro products have been implicated in more than 30 cases of liver injury resulting in liver transplantation in 4 and death in one patient).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], of which one was attributed to an OxyELITE Pro product [Navarro 2014]).
Zheng EX, Navarro VJ. (2015). Liver injury from herbal, dietary, and weight loss supplements: a review. J Clin Transl Hepatol. (Review of literature on liver injury due to HDS products used for weight loss, focusing upon liver injury attributed to Herbalife, Hydroxycut and OxyELITE Pro products which was predominantly hepatocellular [acute hepatitis-like] and had a significant mortality rate).
Johnston DI, Chang A, Viray M, Chatham-Stephens K, He H, Taylor E, Wong LL, et al. (2016). Hepatotoxicity associated with the dietary supplement OxyELITE Pro™ -- Hawaii, 2013. Drug Test Anal. (Clinical and epidemiologic analysis of an outbreak of acute liver injury in Hawaii attributed to use of OxyELITE Pro identified 36 cases, ages 16 to 66 years; 57% women; 23% Asian and 57% reporting 2 or more races; latency 7 days to 2 years, peak median ALT 1740 U/L, Alk P 141 U/L, bilirubin 9.4 mg/dL; 33% with autoimmune markers; 39% hospitalized; 2 patients required liver transplant and one died).
Teschke R, Schwarzenboeck A, Frenzel C, Schulze J, Eickhoff A, Wolff A. (2015). The mystery of the Hawaii liver disease cluster in summer 2013: A pragmatic and clinical approach to solve the problem. Ann Hepatol. (Analysis of cases of liver injury attributed to OxyELITE Pro reported by the CDC, found “pervasive bias” and “poor quality of case management” and suggested that the liver injury was largely due to other causes).
Teschke R, Eickhoff A. (2016). The Honolulu liver disease cluster at the Medical Center: its mysteries and challenges. Int J Mol Sci. (Review of the outbreak of acute liver injury in Honolulu [Roytman 2014] that was attributed to OxyELITE Pro arguing that other causes were not adequately excluded).
Heidemann LA, Navarro VJ, Ahmad J, Hayashi PH, Stolz A, Kleiner DE, Fontana RJ. (2016). Severe acute hepatocellular injury attributed to OxyELITE Pro: a case series. Dig Dis Sci. (Among 1596 patients enrolled in a prospective study of drug induced liver injury in the US between 2004 and 2015, 7 were attributed to exposure to OxyELITE Pro, 6 of which presented in 2013 with an acute hepatitis-like syndrome [mean bilirubin 10.9 mg/dL, ALT 2950 U/L, Alk P all less than 3 times elevated], 3 with acute liver failure and 2 undergoing emergency liver transplantation).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products including more than 50 attributed to OxyELITE Pro, all since 2014).
Chatham-Stephens K, Taylor E, Chang A, Peterson A, Daniel J, Martin C, Deuster P, et al. (2017). Hepatotoxicity associated with weight loss or sports dietary supplements, including OxyELITE Pro™ -- United States, 2013. Drug Test Anal. (Search from several databases for instances of acute liver injury following use of muscle building or weight reducing dietary supplements occurring between April and December 2013, identified 40 cases, 27 of which were linked to use of OxyElite Pro).
Teschke R, Eickhoff A. (2017). Suspected liver injury and the dilemma of causality. Dig Dis Sci. (Letter to the editor in response to Heidemann [2016] questioning the causality assessment as being “vague, unscored, not quantitative and not transparent” invented by a “close-knit US based group”).
Teschke R, Wolff A, Eickhoff A, Danan G. (2018). Is obesity rather than the dietary supplement used for weight reduction the cause of liver injury?. JGH Open. (Review of reports of liver injury attributed to dietary supplements used for weight loss [such as green tea extract, Hydroxycut, Herbalife products and OxyELITE Pro] found that nonalcoholic liver disease was rarely considered responsible for the liver injury rather than the dietary supplement).
Roytman MM, Poerzgen P, Navarro V. (2018). Botanicals and hepatotoxicity. Clin Pharmacol Ther. (Review of the hepatotoxicity of botanical products and the difficulty in their regulation, uses OxyELITE Pro as an example of a weight loss product that was eventually linked to at least 97 cases of acute liver injury including several fatalities and emergency liver transplants).

## OTHER REFERENCE LINKS

1 Recent References on OxyELITE Pro: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(OxyELITE%20Pro/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on OxyELITE Pro: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=OxyELITE%20Pro)